# Decitabine

## OVERVIEW

### Introduction

Decitabine is a cytosine analogue and an intravenously administered antineoplastic agent used in the therapy of myelodysplastic syndromes. Decitabine is associated with a low rate of transient serum enzyme elevations during therapy, but has not been implicated in causing clinically apparent liver injury with jaundice.

### Background

Decitabine (dee sye' ta been) is a pyrimidine analogue (5-aza-deoxy-cytidine) which is the deoxyribose form of 5-azacitidine. Decitabine is converted intracellularly to a triphosphate which becomes incorporated into DNA and appears to inhibit DNA methylation, resulting in increased expression of silenced genes including tumor suppressor genes. Studies done in vitro and in vivo have shown that decitabine induces differentiation of bone marrow cells and results in normalization of bone marrow in a proportion of patients with myelodysplasia. Decitabine was approved for use in the United States in 2006 and the current single indication is for therapy of myelodysplastic syndromes (MDS). Decitabine is available as a powder or solution for injection in 50 mg vials generically and under the trade name of Dacogen. The usual dosage regimen in adults is 15 to 20 mg/m^2^ of body surface area given intravenously (iv) in several day regimens, with repeat cycles every 4 or 6 weeks. A minimum of 4 courses is recommended. Common side effects include bone marrow suppression, nausea, vomiting, diarrhea, stomatitis, bruising, abdominal pain, myalgias, headache, dizziness, fatigue, fever, rash and pruritus.

Decitabine is poorly absorbed orally due to its metabolism by cytidine deaminase found in the intestine and liver. In 2020, cedazuridine, an oral inhibitor of cytidine deaminase, was approved for use with a fixed dose of oral decitabine as treatment of adults with MDS. This oral combination therapy yielded similar plasma concentrations as iv administered decitabine and had similar effects on DNA methylation and clinical responses. The adverse event rates to the oral combination therapy were similar to those of iv decitabine, although direct comparisons were limited to single initial cycles of therapy. The oral form of decitabine is available only as a fixed combination with cedazuridine as tablets of 35 mg of decitabine and 100 mg of cedazuridine under the brand name Inqovi. The oral administration of decitabine avoids the inconvenience and difficulties of its iv administration on multiple days of each course of therapy.

### Hepatotoxicity

In early clinical trials using high doses of decitabine, serum enzyme elevations occurred in up to 16% of patients with underlying liver disease or liver metastases, but rarely in persons without hepatic illness. In subsequent studies, serum ALT elevations were reported in 5% to 15% of treated patients, but all were self-limited and no clinically apparent liver injury was reported. Recent studies have reported elevations in serum bilirubin levels in 7% to 12% of treated patients, but the elevations resolved rapidly and were not associated with other clinical or laboratory evidence of liver injury. Monitoring of serum enzyme levels during treatment is recommended only in patients with concurrent liver disease.

The oral combination therapy of decitabine with cedazuridine appears to have a similar frequency and pattern of adverse events as iv decitabine alone. In several prospective clinical trials, single cycles of oral vs iv decitabine had similar rates of aminotransferase elevations and long term, multi-course regimens of the oral fixed dose combination therapy resulted in serum aminotransferase elevations in 20% to 37% of patients, which were above 5 times the upper limit of normal (ULN) in 2% to 3% with no cases of clinically apparent liver injury attributable to the chemotherapeutic agent.

Thus, despite widescale use as therapy of MDS, decitabine has not been convincingly linked to cases of clinically apparent liver injury. Nevertheless, the frequency of serum enzyme elevations with therapy make it difficult to say that decitabine is totally without potential for causing drug induced liver injury.

Likelihood score: E* (unproven but suspected, rare cause of clinically apparent liver injury).

### Mechanism of Injury

Hepatotoxicity from decitabine appears to be rare and confined mostly to asymptomatic elevations in serum enzymes in patients receiving the highest doses or with underlying liver disease. Thus, the liver injury is likely due to direct toxicity which is generally minimal or mild except in susceptible patients.

### Outcome and Management

The severity of the liver injury linked to decitabine therapy is usually mild in severity and without accompanying symptoms or jaundice. Decitabine has not been linked to cases of severe acute hepatitis, acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between decitabine and other cytidine analogues including azacitidine.

Drug Class: Antineoplastic Agents

Other drugs for myelodysplastic syndromes: Azacitidine, Cedazuridine, Luspatercept

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Decitabine – Generic, Dacogen®

Decitabine and Cedazuridine – Inqovi®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Decitabine) (Decitabine)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Inqovi) (Decitabine and Cedazuridine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Decitabine | 2353-33-5 | 2353-33-5

## ANNOTATED BIBLIOGRAPHY

References updated: 27 July 2023

Abbreviations: AML, acute myelogenous leukemia; iv, intravenous; MDS, myelodysplastic syndrome; sc, subcutaneously.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; decitabine is not discussed).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents; decitabine is not discussed).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Inhibitors of histone deacetylase. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, p. 1203-36. (Textbook of pharmacology and therapeutics).
Wijermans PW, Lü M, Verhoef G, Klimek V, Bosly A. An epigenetic approach to the treatment of advanced MDS; the experience with the DNA demethylating agent 5-aza-2'-deoxycytidine (decitabine) in 177 patients. Ann Hematol 2005; 84: 9-17. (Pooled results of 3 European trials of decitabine in 177 patients with myelodysplasia; response rate was 49%, liver enzyme elevations occurred in 16% of patients in one study and "liver toxicity" was reported in 1% of patients in another, but no case of clinically apparent liver injury or death from liver disease was reported). 16211386
Kantarjian H, Issa JP, Rosenfeld CS, Bennett JM, Albitar M, DiPersio J, Klimek V, et al. Decitabine improves patient outcomes in myelodysplastic syndromes: results of a phase III randomized study. Cancer 2006; 106: 1794-803. (Among 170 patients with myelodysplastic syndromes [MDS] treated with decitabine vs standard of care, hyperbilirubinemia occurred in 7% on decitabine vs none receiving standard care; no mention of ALT elevations). 16532500
Kantarjian H, Oki Y, Garcia-Manero G, Huang X, O'Brien S, Cortes J, Faderl S, et al. Results of a randomized study of 3 schedules of low-dose decitabine in higher-risk myelodysplastic syndrome and chronic myelomonocytic leukemia. Blood 2007; 109: 52-7. (95 patients with severe myelodysplasia or chronic leukemia were randomized to 3 regimens of decitabine [iv or sc for 5 days, or iv at half dose for 10 days]; ALT elevations occurred in 14 patients [15%] and were above 5 times ULN in 4 [4%], but all resolved and none required dose modification or discontinuation). 16882708
Aribi A, Borthakur G, Ravandi F, Shan J, Davisson J, Cortes J, Kantarjian H. Activity of decitabine, a hypomethylating agent, in chronic myelomonocytic leukemia. Cancer 2007; 109: 713-7. (Among 19 patients with chronic leukemia treated with decitabine intravenously [iv] or subcutaneously for 5-10 days every 4 weeks, one had ALT elevations above 5 times ULN, but "non-hematologic side effects were minimal"). 17219444
Jabbour E, Issa JP, Garcia-Manero G, Kantarjian H. Evolution of decitabine development: accomplishments, ongoing investigations, and future strategies. Cancer 2008; 112: 2341-51. (Review of structure, mechanism of action, pharmacokinetics, efficacy in various conditions and safety of decitabine; hyperbilirubinemia occurred in up to 12% of patients receiving decitabine, but ALT elevations and cause of bilirubin rise were not discussed). 18398832
Steensma DP, Baer MR, Slack JL, Buckstein R, Godley LA, Garcia-Manero G, Albitar M, et al. Multicenter study of decitabine administered daily for 5 days every 4 weeks to adults with myelodysplastic syndromes: the alternative dosing for outpatient treatment (ADOPT) trial. J Clin Oncol 2009; 27: 3842-8. (Among 99 patients with MDS treated with decitabine [20 mg/m2] daily for 5 days every 28 days, one patient died of hepatic failure, but no details given). 19528372
Garcia JS, Jain N, Godley LA. An update on the safety and efficacy of decitabine in the treatment of myelodysplastic syndromes. Onco Targets Ther 2010; 3: 1-13. (Systematic review of safety and efficacy of decitabine in MDS; liver dysfunction was reported in 1-11% of patients, but details not provided or discussed). 20616953
Kantarjian HM, Thomas XG, Dmoszynska A, Wierzbowska A, Mazur G, Mayer J, Gau JP, et al. Multicenter, randomized, open-label, phase III trial of decitabine versus patient choice, with physician advice, of either supportive care or low-dose cytarabine for the treatment of older patients with newly diagnosed acute myeloid leukemia. J Clin Oncol 2012; 30: 2670-7. (Among 485 patients with AML treated with decitabine, cytarabine or supportive care, adverse events were similar with decitabine and cytarabine; no discussion of ALT elevations or liver injury). 22689805
Lee YG, Kim I, Yoon SS, Park S, Cheong JW, Min YH, Lee JO, et al. Comparative analysis between azacitidine and decitabine for the treatment of myelodysplastic syndromes. Br J Haematol 2013; 161: 339-47. (Observational study comparing safety and efficacy of azacitidine vs decitabine in 300 Korean patients with MDS, found similar rates of efficacy and side effects; no mention of ALT elevations or hepatotoxicity). 23432512
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents, but none were linked to decitabine treatment). 25754159
Salim O, Toptas T, Avsar E, Yucel OK, Ozturk E, Ferhanoglu B, Geduk A, et al. Azacitidine versus decitabine in patients with refractory anemia with excess blast-results of multicenter study. Leuk Res 2016; 45: 82-9. (Among 88 patients with refractory anemia treated with azacitidine or decitabine followed at 6 Turkish referral centers, overall survival, transfusion requirements and rates of adverse events and acute leukemia were similar in the two groups; no mention of ALT elevations or hepatotoxicity). 27107658
Nieto M, Demolis P, Béhanzin E, Moreau A, Hudson I, Flores B, Stemplewski H, et al. The European Medicines Agency review of decitabine (Dacogen) for the treatment of adult patients with acute myeloid leukemia: summary of the scientific assessment of the Committee for Medicinal Products for Human Use. Oncologist 2016; 21: 692-700. (Review of the efficacy and safety of decitabine by a European expert panel concluded that its use should be limited to adults over the age of 65 with AML who are not candidates for standard induction therapy; and that adverse events are similar to those of low dose cytarabine, largely due to myelosuppression; no mention of ALT elevations or hepatotoxicity). 27091416
Jabbour E, Short NJ, Montalban-Bravo G, Huang X, Bueso-Ramos C, Qiao W, Yang H, et al. Randomized phase 2 study of low-dose decitabine vs low-dose azacitidine in lower-risk MDS and MDS/MPN. Blood 2017; 130: 1514-22. (Among 113 patients with lower-risk MDS treated with low doses of azacitidine or decitabine, overall response rates favored decitabine [70% vs 49%], as did rates of transfusion independence and cytogenetic responses, and both therapies were "overall well tolerated"; no mention of ALT elevations or hepatotoxicity). 28774880
Savona MR, Odenike O, Amrein PC, Steensma DP, DeZern AE, Michaelis LC, Faderl S, et al. An oral fixed-dose combination of decitabine and cedazuridine in myelodysplastic syndromes: a multicentre, open-label, dose-escalation, phase 1 study. Lancet Haematol. 2019;6:e194-e203. (Among 44 patients with various MDS treated with intravenous (iv) decitabine or various combinations of oral decitabine and cedazuridine, oral doses of 30 or 40 mg of decitabine and 100 mg of cedazuridine yielded 5-day area under the curve concentrations most similar to iv decitabine with similar adverse event rates and ALT elevations in 20% of subjects, all values being less than 3 times ULN). 30926081
Zhou H, Qin P, Liu Q, Yuan C, Hao Y, Zhang H, Wang Z, et al. A prospective, multicenter study of low dose decitabine in adult patients with refractory immune thrombocytopenia. Am J Hematol. 2019;94:1374-1381. (Among 45 adults with refractory idiopathic thrombocytopenic purpura treated with low doses of decitabine [3.5 mg/m^2^ for 3 days in three 28-day cycles], 23 had a clinical response usually within 14-70 days, some requiring retreatment, with a 29% adverse event rate [none severe] including 2 patients with ALT elevations, both of which were transient and less than 3 times ULN ). 31591739
Lee BH, Kang KW, Jeon MJ, Yu ES, Kim DS, Choi H, Lee SR, et al. Comparison between 5-day decitabine and 7-day azacitidine for lower-risk myelodysplastic syndromes with poor prognostic features: a retrospective multicentre cohort study. Sci Rep. 2020;10:39. (Among 111 adults with low- or intermediate-risk MDS treated with iv decitabine [20 mg/m^2^ for 5 days] or azacitidine [75 mg/m^2^ for 7 days], overall response rates were higher with decitabine [67% vs 44%] while adverse event rates were similar; no mention of ALT elevations or hepatotoxicity). 31913293
Dhillon S. Decitabine/Cedazuridine: first approval. Drugs. 2020;80:1373-1378. (Review of the mechanism of action, history of development, pharmacokinetics, clinical efficacy, and safety of the combination of oral decitabine and cedazuridine shortly after its approval for use in MDS in the US, discusses adverse events of myelosuppression and gastrointestinal upset but does not mention ALT elevations or hepatotoxicity). 32860582
Garcia-Manero G, Griffiths EA, Steensma DP, Roboz GJ, Wells R, McCloskey J, Odenike O, et al. Oral cedazuridine/decitabine for MDS and CMML: a phase 2 pharmacokinetic/pharmacodynamic randomized crossover study. Blood. 2020;136:674-683. (Among 80 patients with MDS or chronic myelomonocytic leukemia treated with oral cedazuridine/decitabine or iv decitabine alone for 5 days in cycle one with cross over to the other regimen in cycle 2, area-under-the-curve plasma concentrations were similar in both groups as were demethylation rates and the clinical response rate with continued cycles of combination therapy was 60%; common adverse events were neutropenia and thrombocytopenia; no mention of ALT elevations or hepatotoxicity). 32285126
Sekeres MA, Taylor J. Diagnosis and treatment of myelodysplastic syndromes: a review. JAMA. 2022;328:872-880. (Concise review of clinical features, natural history, diagnosis, and management of MDS; adverse events are listed in tables but without mention or discussion of ALT elevations or hepatotoxicity). 36066514
Kim N, Norsworthy KJ, Subramaniam S, Chen H, Manning ML, Kitabi E, Earp J, et al. FDA approval summary: decitabine and cedazuridine tablets for myelodysplastic syndromes. Clin Cancer Res. 2022;28:3411-3416. (Summary of the basis for the FDA approval of an oral fixed dose combination of decitabine and cedazuridine with efficiency and safety results from a phase 3 open-label trial in 133 patients which demonstrated complete remissions in 18-21% of subjects and with an adverse event profile similar to that of iv decitabine; ALT elevations arose in 37% of patients but were above 5 times ULN in only 2%; no mention of serious hepatic adverse events). 35435961
Liu H, Jiang H, Tong H, Xia R, Yang L, Zhao H, Ouyang J, et al. Decitabine in patients with myelodysplastic syndromes: A multi-center, open-label, dose comparison trial. Cancer Med. 2023;12:13885-13893. (Among 191 adults with intermediate- or high-risk MDS treated with decitabine in a standard [20 mg/m^2^ for 5 days] or extended regimen [12 mg/m^2^ for 8 days] per each of 4 cycles, overall response rates were similar [42% vs 38%] as were adverse event rates, including for grade 3 or above “hepatobiliary” events which arose in 3.2% vs 5.2%). 37350499
Garcia-Manero G. Myelodysplastic syndromes: 2023 update on diagnosis, risk-stratification, and management. Am J Hematol. 2023;98:1307-1325. (Review of the classification of MDS and risk categorization with an update on management including discussion of hypomethylation agents and luspatercept; no mention of ALT elevations or hepatotoxicity). 37288607
Randall MP, DeZern AE. The management of low-risk myelodysplastic syndromes-current standards and recent advances. Cancer J. 2023;29:152-159. (Review of treatment of low-risk MDS including erythropoietin, iron chelation, lenalidomide, luspatercept and low dose hypomethylating agents; no discussion of hepatotoxicity). 37195771

## OTHER REFERENCE LINKS

Recent References on Decitabine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Decitabine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Decitabine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Decitabine)